# Ethosuximide

## OVERVIEW

### Introduction

Ethosuximide is an succinimide based anticonvulsant commonly used for absence (petit mal) seizures in both adults and children. Ethosuximide has been associated with rare instances of serum enzyme elevations during treatment, but has not been linked to cases of clinically apparent liver injury with jaundice.

### Background

Ethosuximide (eth' oh sux" a mide) is a succinimide derivative and potent anticonvulsant that has been used to treat absence (petit mal) seizures for more than 50 years. Ethosuximde reduces theshold calcium currents in thalamic neurons and suppresses the paroxysmal spike and wave activity that is associated with lapses of consciousness that occur with absence seizures. Ethosuximide was approved for use in epilepsy in 1960 for use alone or in combination with other agents to treat absence seizures. Ethosuximide is available as tablets of 250 mg and as syrup for pediatric use in several generic forms and under the brand name of Zarontin. The recommended initial dose in adults and children above the age of 6 years is 250 mg twice daily with dose escalation weekly based upon tolerance and effect. Common side effects include dizziness, somnolence, ataxia, fatigue, irritability, anorexia and epigastric discomfort. Rare, but potentially severe adverse events include hypersensitivity reactions and drug induced lupus erythematosus and scleroderma.

### Hepatotoxicity

Prospective studies suggest that chronic ethosuximide therapy is not accompanied by significant elevations in serum aminotransferase levels, but can increase gamma glutamyltranspeptidase levels. Clinically apparent hepatotoxicity from ethosuximide is very rare with few case reports published despite use of this agent for half a century. Futhermore, the liver injury in reported cases was usually mild and asymptomatic and a part of a generalized hypersensitivity syndrome with fever, rash, facial edema, lymphadenopathy, and eosinophilia or atypical lymphocytosis. The usual latency to onset of the hypersensitivity syndrome is 2 to 8 weeks. The typical serum enzyme elevations are a mixed-cholestatic-hepatocellular pattern and reported cases have not been jaundiced. While the product labeling for ethosuximide warns of hepatic dysfunction and recommends periodic monitoring of liver tests, clinically apparent liver injury with jaundice from ethosuximide is rare.

Likelihood score: E* (suspected but unproven cause of clinically apparent liver injury).

### Mechanism of Injury

Ethosuximide is metabolized to inactive intermediates in the liver via the cytochrome P450 system (CYP 3A4). The mechanism of ethosuximide hepatotoxicity is unknown but is likely to be hypersensitivity to an metabolic intermediate.

### Outcome and Management

Reported instances of liver injury from ethosuximide have consisted of transient, asymptomatic serum enzyme elevations or mild liver injury accompanying skin rash and systemic hypersensivity reactions. Ethosuximide has not been linked to cases of chronic hepatitis, vanishing bile duct syndrome or acute liver failure. The liver injury resolves rapidly with discontinuation of ethosuximide and typically recurs rapidly with reexposure, which should be avoided. There does not appear to be cross reactivity to hypersensitivity reactions or liver injury between ethosuximide and other antiseizure medications including the aromatic anticonvulsants, but caution and careful monitoring should be used in switching to another anticonvulsant after a hypersensitivity reaction to ethosuximide.

Drug Class: Anticonvulsants

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ethosuximide – Zarontin®

DRUG CLASS

Anticonvulsants

COMPLETE LABELING

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Ethosuximide | 77-67-8 | C7-H11-N-O2 | Ethosuximide chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 19 February 2018

Zimmerman HJ. Anticonvulsants. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 498-516. (Expert review of anticonvulsants and liver injury published in 1999; ethosuximide is not discussed).
Pirmohamed M, Leeder SJ. Anticonvulsant agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013: pp 423-442. (Review of anticonvulsant induced liver injury; ethosuximide is not discussed).
McNamara JO. Pharmacology of the epilepsies. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 583-607. (Textbook of pharmacology and therapeutics).
Teoh OT, Wong PK. Lupus-scleroderma syndrome induced by ethosuximide. Arch Dis Child 1975; 50: 658-61. (16 year old Chinese girl with epilepsy on 4 anticonvulsants including ethosuximide for 4 years developed arthritis, sclerodactyly, rash and hepatomegaly [liver tests normal, ANA and LE prep positive], symptoms and laboratory abnormalities resolving on stopping all drugs except phenobarbital, subsequently tolerating phenytoin but having recurrence of fever and rash 3 weeks after restarting ethosuximide). 812426
Reynolds NC Jr, Miska RM. Safety of anticonvulsants in hepatic porphyrias. Neurology 1981; 31: 480-4. (Mentions that ethosuximide has been associated with triggering attacks of acute intermittent porphyria). 7194443
Coulter DL. Ethosuximide-induced liver dysfunction. Arch Neurol 1983; 40: 393-4. (1 year old boy developed ALT elevations one month after ethosuximide was added to a chronic regimen of valproate and phenobarbital that continued to worsen after stopping valproate [bilirubin normal, ALT 69 rising 229 U/L, GGT 175 U/], and resolved rapidly when ethosuximide was stopped). 6847455
Wyllie E, Wyllie R. Routine laboratory monitoring for serious adverse effects of antiepileptic medications: the controversy. Epilepsia 1991; 32 Suppl 5: S74-9. (Review of adverse effects of phenytoin, valproate, carbamazepine and ethosuximide with discussion of potential role of routine monitoring of laboratory results such as ALT; most information indicates that such monitoring is unlikely to be effective in avoiding the rare instance of severe idiosyncratic hepatic injury from anticonvulsants because of their rarity and rapidity of onset and the frequent, insignificant ALT elevations found; mentions aplastic anemia and leucopenia as being due to ethosuximide, but not hepatic injury). 1743173
Conilleau V, Dompmartin A, Verneuil L, Michel M, Leroy D. Hypersensitivity syndrome due to 2 anticonvulsant drugs. Contact Dermatitis 1999; 41: 141-4. (6 year old boy with petit mal developed rash, fever, lymphadenopathy and eosinophilia a month after starting ethionamide and valproate [bilirubin not given, AST 70 U/L, GGT 50 U/L], redeveloping rash within a day of restarting ethosuximide, later tolerating lamotrigine and clonazepam). 10475512
Knowles SR, Shapiro LE, Shear NH. Anticonvulsant hypersensitivity syndrome: incidence, prevention and management. Drug Saf 1999; 21: 489– 501. (Review of anticonvulsant hypersensitivity syndrome: triad of fever, rash and internal organ injury occurring 1-8 weeks after exposure to anticonvulsant; liver being most common internal organ involved. Occurs in 1:1000-1:10,000 initial exposures to phenytoin, carbamazepine, phenobarbital or lamotrigine, unrelated to dose, perhaps predisposed by valproate; liver injury arises 1-4 weeks after onset of rash and ranges in severity from asymptomatic ALT elevations to icteric hepatitis to ALF; high mortality rate with jaundice; other organs include muscle, kidney, brain, heart and lung. Pseudolymphoma syndrome and serum sickness like syndrome are separate complications of anticonvulsants; role of corticosteroids uncertain; cross reactivity among the agents should be assumed; ethosuximide is not mentioned). 10612272
Hamer HM, Morris HH. Hypersensitivity syndrome to antiepileptic drugs: a review including new anticonvulsants. Clevel Clin J Med 1999; 66: 239-45. (Clinical review of anticonvulsant syndrome, which occurs in 1-5/10,000 users, higher risk in African Americans and affected siblings; liver involvement common, but most cases are anicteric; other manifestations include facial edema, lymphadenopathy, bone marrow aplasia, pseudolymphoma, thyroiditis, interstitial nephritis, switching to valproate, levetiracetam or benzodiazepines is safe; ethosuximide is not mentioned). 10199060
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the United States between 1990 and 2002, 137 [0.2%] were done for idiosyncratic drug induced acute liver failure, of which 10 were attributed to phenytoin, 10 to valproate and 1 to carbamazepine, but none to ethosuximide or other anticonvulsants). 15390328
Björnsson E. Hepatotoxicity associated with antiepileptic drugs. Acta Neurol Scan 2008; 118: 281-90. (Review of all anticonvulsants; mentions that there is no known clinically significant hepatotoxicity associated with ethosuximide). 18341684
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, valproate accounted for 6 cases, lamotrigine 5, phenytoin 5, gabapentin and topiramate 1 each; none were due to ethosuximide). 18955056
Posner E. Absence seizures in children. Clin Evid (Online) 2008 Jan 10;2008. (Review of evidence of efficacy and safety of drugs for petit mal seizures in children; ethosuximide is considered effective, but there are no randomized controlled trials to support this consensus; mentions that hepatic impairment, aplastic anaemia and serious skin reactions are rare adverse effects of ethosuximide). 19450342
Penovich PE, Willmore LJ. Use of a new antiepileptic drug or an old one as first drug for treatment of absence epilepsy. Epilepsia 2009; 50 Suppl 8:37-41. (Review of the therapy of absence seizures, mentions that side effects of ethosuximide "tend to be a challenge"; no mention of hepatotoxicity). 19702732
Knowles SR, Dewhurst N, Shear NH. Anticonvulsant hypersensitivity syndrome: an update. Expert Opin Drug Saf 2012; 11: 767-78. (Updated review of anticonvulsant hypersensitivity syndrome; associated with phenytoin, phenobarbital, lamotrigine and carbamazepine and rarely with zonisamide, valproate and oxcarbazepine; ethosuximide not mentioned). 22794330
Drugs for epilepsy. Treat Guidel Med Lett 2013; 11: 9-18. (Concise review of indications and side effects of anticonvulsants; ethosuximide is approved for treatment of absence seizures, but is not effective in generalized tonic-clonic or partial seizures; rare side effects include severe skin and generalized hypersensitivity reactions; no mention of hepatotoxicity). 23348233
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to ethosuximide). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 40 [4.5%] were attributed to anticonvulsants, but none specificaly to ethosuximide). 25754159
Gironell A, Marin-Lahoz J. Ethosuximide for essential tremor: an open-label trial. Tremor Other Hyperkinet Mov (N Y) 2016; 6: 378. (A small trial of ethosuximide in 15 elderly patients with essential tremor was discontinued early because of side effects of headache, dizziness and anxiety, and lack of any effect on tremor in those able to tolerate treatment; no mention of ALT elevations). 27625899
Drugs for epilepsy. Med Lett Drugs Ther 2017; 59 (1526): 121-30. (Concise review of the drugs available for therapy of epilepsy lists ethosuximide as the drug of choice for absence seizures and mentions that it is generally well tolerated, but rare adverse events can include erythema multiforme, Stevens Johnson syndrome and systemic lupus erythematosus; no mention of ALT elevations or hepatotoxicity). 28746301
Vidaurre J, Gedela S, Yarosz S. Antiepileptic drugs and liver disease. Pediatr Neurol 2017; 77: 23-36. (Review of the use of anticonvulsants in patients with liver disease mentions that close monitoring is advised when using ethosuximide in patients with hepatic disfunction, but that reports of hepatoxicity of ethosuximide have been few and usually confounded by its use with other agents). 29097018
Toyama T, Asano Y, Taniguchi T, Takahashi T, Ichimura Y, Tamaki Z, Kagami S, et al. Ethosuximide-induced lupus-scleroderma syndrome with disease-specific autoantibodies. Eur J Dermatol 2017; 27: 196-7. (8 year old Japanese girl with absence seizures developed fever, cold fingers, oral ulcers, arthralgias abd sclerodactyly one month after starting ethosuximide [ANA and anti-dsDNA positive, ESR elevated, "and slightly elevated transaminases"], resolving slowly with stopping). 28026802
Tachibana K, Hamada T, Tsuchiya H, Shibata T, Fujii K, Kobayashi K, Iwatsuki K. Ethosuximide-induced Stevens-Johnson syndrome: beneficial effect of early intervention with high-dose corticosteroid therapy. J Dermatol 2018 Feb 11. [Epub ahead of print] (Two 4 year old children with absence seizures developed Stevens Johnson syndrome 2 and 3 weeks after starting ethosuximide [bilirubin and Alk P not provided, AST 186 and 45 U/L], resolving rapidly with immediate therapy with intravenous corticosteroids). 29430697

## OTHER REFERENCE LINKS

1. Recent References on Ethosuximide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(ethosuximide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/11/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ethosuximide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=ethosuximide)